# Wilson Disease Agents

## OVERVIEW

Wilson disease is an inherited abnormality of copper metabolism that leads to excess copper accumulation and injury to liver, brain and other organs. The metabolic defect in Wilson disease is caused by mutations in ATPase7B, a hepatic enzyme responsible for transmembrane transport and excretion of copper into the bile. The metabolic defect leads to accumulation of free copper in liver and blood and secondarily in other organs, particularly brain and kidney. The disease usually presents in childhood or adolescence with neurologic syndromes, signs of advanced liver disease and hemolytic anemia. If untreated it is invariably fatal, death being from progressive neurologic disease or acute or chronic liver failure. Therapy of Wilson disease is usually based upon copper chelation, but limitation of copper in the diet and approaches to inhibiting copper absorption can also be important.

Copper chelating agents available in the United States include penicillamine, trientine and dimercaprol. These agents lower blood and tissue copper levels and, when given chronically, prevent copper accumulation and injury in Wilson disease. Penicillamine is considered the first line therapy of Wilson disease, but is often limited by its unique side effects that can be severe and may be dose limiting. Trientine is a second line agent and is less effective than penicillamine in chelating copper, but it has fewer serious side effects and is generally well tolerated. Both of these agents are given orally. Dimercaprol (also known as British anti-Lewisite or BAL) was the initial copper chelating agent developed for Wilson disease, but it requires parenteral administration and has frequent serious adverse effects. Dimercaprol is currently rarely used for Wilson disease and generally only in conjunction with oral copper chelating agents, for a short period of time, and in patients with severe symptomatic disease. Zinc is also useful in managing Wilson disease and acts by inhibition of copper absorption, rather than chelation of excess copper in tissue or the circulation. Zinc has been used as a first line therapy, but is currently recommended largely as maintenance therapy once chelation of excess copper has been accomplished.

Among the drugs used for Wilson disease, only penicillamine has been linked to cases of clinically apparent liver injury. Penicillamine has been linked to cases of acute, immunoallergic hepatitis which is likely due to hypersensitivity.

Information on the mechanism of action, clinical use and potential hepatotoxicity of the agents used to treat Wilson disease are given in the individual drug records for each of the following:

- Dimercaprol
- Penicillamine
- Trientine
- Zinc

## ANNOTATED BIBLIOGRAPHY

References updated: 25 July 2020

Byrns MC, Penning TM. Treatment of metal exposure. Environmental toxicology: carcinogens and heavy metals. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1311-5. (Textbook of pharmacology and therapeutics).
Walshe JM. (1956). Penicillamine, a new oral therapy for Wilson's disease. Am J Med. (Initial studies on efficacy of oral penicillamine [ β,β-dimethyl cysteine, a monothiol] in inducing cupruresis in Wilson disease and lack of effect of cysteine and methionine; no toxic reactions were observed).
Sternlieb I, Scheinberg IH. (1968). Prevention of Wilson's disease in asymptomatic patients. N Engl J Med. (Among 42 asymptomatic persons who were diagnosed with Wilson disease and treated with penicillamine for up to 8 years, none developed symptomatic disease).
Walshe JM. (1982). Treatment of Wilson’s disease with trientine (triethylene tetramine) dihydrochloride. Lancet. (Among 20 patients with Wilson disease who were intolerant of penicillamine therapy, all responded to trientine therapy, although complications of penicillamine [lupus syndrome, elastosis perforans] did not always improve; no evidence of toxicity including hepatotoxicity).
Hoogenraad TU, Van den Hamer CJ. (1983). 3 years of continuous oral zinc therapy in 4 patients with Wilson's disease. Acta Neurol Scand. (4 patients [17 to 46 year old men] with Wilson disease previously treated with penicillamine were treated with oral zinc for at least 3 years and all showed clinical improvement and no adverse events, including no changes in liver tests during zinc therapy).
Brewer GJ, Hill GM, Prasad AS, Cossck ZT, Rabbani P. (1983). Oral zinc therapy for Wilson’s disease. Ann Intern Med. (5 patients [25 to 34 years old, 3 men, 2 women] with stable Wilson disease after penicillamine therapy underwent careful copper balance studies while on zinc therapy alone, demonstrating a negative copper balance largely due to increased fecal loss).
Brewer GJ, Dick RD, Johnson VD, Brunberg JA, Kluin KJ, Fink JK. (1998). Treatment of Wilson's disease with zinc: XV long-term follow-up studies. J Lab Clin Med. (Description of patterns of change in urinary, hepatic and serum copper and zinc levels and liver tests in 141 patients with Wilson disease treated with zinc; adverse reactions were "minimal", the most common being initial abdominal discomfort).
Vilensky JA, Redman K. (2003). British anti-Lewisite (dimercaprol): an amazing history. Ann Emerg Med. (History of development and use of dimercaprol, initially synthesized at Oxford during WWII as a means of reversing Lewisite arsenical gas poisoning [thus British anti-Lewisite (BAL)] and now still used for emergency therapy of heavy metal poisoning: arsenic, gold, copper and mercury).
Ala A, Walker AP, Ashkan K, Dooley JS, Schilsky ML. (2007). Wilson's disease. Lancet. (Review of the clinical features, pathogenesis, genetics, diagnosis and treatment).
Roberts EA, Schilsky ML. (2008). AASLD. Diagnosis and treatment of Wilson disease: an update. Hepatology. (Thorough review of the cause, natural history, diagnosis and treatment of Wilson disease with specific recommendations for use of penicillamine, trientine and zinc).
Walshe JM. (2009). The conquest of Wilson's disease. Brain. (History of the initial description of Wilson disease, its link to copper accumulation, and therapies several of which were developed by the author).
Weiss KH, Stremmel W. (2012). Evolving perspectives in Wilson disease diagnosis: treatment and monitoring. Curr Gastroenterol Rep. (Review of the diagnosis and management of Wilson disease, including the role of genetic testing and the choice of medical therapies).
Weiss KH, Thurik F, Gotthardt DN, Schäfer M, Teufel U, Wiegand F, Merle U, et al. (2013). EUROWILSON Consortium. Efficacy and safety of oral chelators in treatment of patients with Wilson disease. Clin Gastroenterol Hepatol. (Among 467 patients with Wilson followed in a retrospective, multicenter study for an average of 13 years, penicillamine and trientine appeared to be equally effective in reversing the liver disease, and while penicillamine had lower rates of neurological worsening [2% vs 11%], it had higher rates of discontinuations due to adverse reactions [29% vs 7%]; there were no deaths from adverse reactions and no mention of hepatotoxicity).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which was attributed to an agent used to treat Wilson disease).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one case was attributed to penicillamine [cholestatic hepatitis in a woman with scleroderma], but none were attributed to drugs being used for Wilson disease).
Pfeiffenberger J, Beinhardt S, Gotthardt DN, Haag N, Freissmuth C, Reuner U, Gauss A, et al. (2018). Pregnancy in Wilson's disease: management and outcome. Hepatology. (Among 282 pregnancies in 136 patients with Wilson disease analyzed in a retrospective, multicenter study, spontaneous abortion was less common among patients being treated with penicillamine [17%] or zinc [10%] than untreated patients [41%], which was proportionally greater than with trientine [28%] and similar to that in patients who discontinued therapy during pregnancy [36%]; worsening of liver disease arose in some patients on treatment but was self-limiting and resolved after delivery; birth defects were found in 7 of 209 [3%] newborns and did not vary with chelator use or appear to be drug related, suggesting that chelation therapy should be continued during pregnancy).
Roberts EA. (2018). Update on the diagnosis and management of Wilson disease. Curr Gastroenterol Rep. (Review of recent advances in the understanding of the pathogenesis, clinical features, diagnosis, and treatment of Wilson disease).